# Melphalan

## OVERVIEW

### Introduction

Melphalan is an orally and parenterally administered nitrogen mustard-like alkylating agent used in the therapy of multiple myeloma and ovarian cancer. Melphalan therapy has been associated with low rates of serum enzyme elevations during therapy, but when used in high doses as myeloablative therapy in preparation for hematopoietic cell transplantation, it is associated with high rates of enzyme elevations and acute liver injury due to sinusoidal obstruction syndrome.

### Background

Melphalan (mel' fa lan) is a phenylalanine derivative of nitrogen mustard and an alkylating agent that resembles cyclophosphamide and chlorambucil. It acts by causing modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis and causing programmed cell death (apoptosis) in rapidly dividing cells. Melphalan was approved for use in the United States in 1964. Current indications for oral melphalan include multiple myeloma and some forms of ovarian carcinoma, usually in combination with other antineoplastic agents. Melphalan is also used parenterally in myeloablative regimens in preparation for hematopoietic cell transplantation and experimentally in high doses in local-regional therapy of metastatic cancer. Melphalan is available as tablets of 2 mg and as a powder for intravenous use in vials of 50 mg generically and under the trade name of Alkeran. The recommended dose varies by indication, body weight and renal function. Melphalan is often given in cycles of 1 to 3 weeks, with 2 to 4 week intervals between cycles. Melphalan shares common side effects with nitrogen mustards and other alkylating agents; these side effects include nausea, vomiting, diarrhea, alopecia, pruritus, bone marrow suppression, oral ulceration, rash and hypersensitivity reactions. Uncommon, but potentially severe adverse reactions include irreversible myelosuppression, hemoloytic anemia, pulmonary fibrosis and interstitial pneumonitis, hepatotoxicity and anaphylaxis.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are uncommon with standard doses of melphalan, but occur more commonly with high dose intravenous regimens. The enzyme elevations are usually mild and asymptomatic and do not require dose modification. Clinically apparent liver disease has not been reported with standard doses of melphalan in chemotherapeutic regimens. However, use of high doses of melphalan in preparation for hematopoietic cell (bone marrow and stem cell) transplantation or in local-regional therapy has been associated with sinusoidal obstruction syndrome that can be severe, leading to acute liver failure and death. Onset of sinusoidal obstruction syndrome is usually within 1 to 3 weeks of the myeloablative or high dose therapy, and is characterized by the onset of abdominal pain, hepatomegaly, weight gain and ascites followed by jaundice. The pattern of serum enzyme elevations is usually hepatocellular, with marked increases in serum aminotransferase and lactic dehydrogenase levels and minimal increase in alkaline phosphatase. The severity of injury varies considerably. In mild forms there is serum enzyme elevations without jaundice and with few or no symptoms. In severe instances, there are elevations in prothrombin time and progressive jaundice and hepatic failure. Immunoallergic and autoimmune features are uncommon. The fatality rate is high. Liver biopsy shows centrolobular necrosis and congestion with occlusion of small veins and red cells in sinusoids.

Melphalan has also been used in the regional therapy of nonresectable cancers in a limb, solid organ or even the liver. In isolated, hyperthermic hepatic perfusion with chemotherapeutic agents, the liver is isolated surgically and perfused with melphalan, with or without tumor necrosis factor (or other antineoplastic agents). The perfusion typically lasts for at least 1 hour and results in a high rate of tumor regression, but with a high rate of hepatotoxicity. At least 80% of patients develop significant serum aminotransferase elevations (5 to 20 times ULN) and two-thirds develop jaundice transiently. The liver injury can be severe and even fatal if complicated by severe sinusoidal obstruction syndrome, direct cytotoxicity or hyperthermia or ischemic injury.

Finally, melphalan is a cytotoxic and immunosuppressive agent and has been linked to rare instances of reactivation of hepatitis B which can be severe and even fatal. Reactivation typically occurs in patients with inactive hepatitits B with HBsAg, but no HBeAg and no or only low levels of HBV DNA in serum before treatment. Reactivation is marked by sudden rise in HBV DNA levels and subsequent increases in ALT and, in severe instances, jaundice and signs of hepatic failure. Reactivation can also occur in patients who are HBsAg and HBV DNA negative, but have anti-HBc in serum with or without anti-HBs, a serologic pattern suggestive of recovery from hepatitis B. In this situation, referred to as “reverse seroconversion”, HBV DNA levels arise followed by HBsAg and serum enzyme elevations. Reverse seroconversion tends to be severe. Most cases of reactivation of hepatitis B attributed to cytotoxic alkylating agents such as melphalan have occurred in patients who are also receiving high doses of corticosteroids, which on their own can lead to reactivation. The combination of the two immunosuppressive agents is probably more likely to cause reactivation than either alone.

Likelihood score: B[H] (likely cause of clinically apparent liver injury when used in high doses).

### Mechanism of Injury

The mechanism of hepatotoxicity from melphalan is probably direct cytotoxic injury to sinusoidal endothelial cells causing their death and extrusion into sinusoids, with subsequent obstruction of sinusoids and small hepatic veins. The cytotoxic and immunosuppressive activity of melphalan may also be responsible for the risk of reactivation of hepatitis B. Melphalan has minimal hepatic metabolism and has not been reported to have significant drug-drug interactions. Cases with features of idiosyncratic liver injury have not been described.

### Outcome and Management

The severity of sinusoidal obstruction syndrome varies considerably, from transient mild asymptomatic liver injury to acute liver failure that is rapidly fatal. There is no known specific therapy of proven efficacy for sinusoidal obstruction syndrome and management should focus on avoidance of further injury and supportive care. Rechallenge should not be done. Reactivation of hepatitis B can be prevented by prophylactic therapy with antiviral agents active against HBV, such as tenofovir and entecavir. Patients with serious malignancies undergoing systemic chemotherapy, such as with melphalan, should be screened for HBsAg and anti-HBc before starting chemotherapy and offered prophylaxis if HBsAg positive and monitored closely if HBsAg negative but anti-HBc positive.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Melphalan – Generic, Alkeran®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Melphalan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Melphalan | 148-82-3 | C13-H18-Cl2-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2020

Abbreviations used: SOS, sinusoidal obstruction syndrome; HCT, hematopoietic cell transplantation.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that melphalan has not been linked to significant liver injury although high doses can cause serum enzyme elevations).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 551. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that melphalan has little or no effect on liver tests).
Wellstein A, CGiaccone G, Atkins MB, Sausville EA. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-202. (Textbook of pharmacology and therapeutics).
Singhal S, Powles R, Treleaven J, Horton C, Swansbury GJ, Mehta J. (1996). Melphalan alone prior to allogeneic bone marrow transplantation from HLA-identical sibling donors for hematologic malignancies: alloengraftment with potential preservation of fertility in women. Bone Marrow Transplant. (28 patients undergoing bone marrow transplantation for leukemia or lymphoma received melphalan alone as conditioning agent; 9 [32%] died, but none of liver disease and no mention of veno-occlusive disease; 3 of 4 surviving women were able to bear children after therapy and transplantation).
Rollins BJ. (1986). Hepatic veno-occlusive disease. Am J Med. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease which is now referred to as sinusoidal obstruction syndrome [SOS]).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, SOS developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Bearman SI. (1995). The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood. (Review of hepatic SOS after bone marrow transplantation [now referred to as hematopoietic cell transplantation [HCT]; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation, with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury).
Eggermont AM, Schraffordt Koops H, Klausner JM, Kroon BBR, Schlag PM, Lienard D, et al. (1996). Isolated limb perfusion with tumor necrosis factor and melphalan for limb salvage in 186 patients with locally advanced soft tissue extremity sarcomas: the cumulative multicenter European experience. Ann Surg. (Among 186 patients with sarcoma undergoing isolated limb perfusion with tumor necrosis factor and melphalan, some systemic adverse events occur, perhaps because of leakage; ALT elevations above 5 times ULN occurred in 6 patients [3%] but no other hepatic adverse events mentioned).
Moreau P, Fiere D, Bezwoda WR, Facon T, Attal M, Laporte JP, Colombat P, et al. (1997). Prospective randomized placebo-controlled study of granulocyte-macrophage colony-stimulating factor without stem-cell transplantation after high-dose melphalan in patients with multiple myeloma. J Clin Oncol. (Among 102 patients with multiple myeloma given high doses of melphalan, 20% had AST and 12% bilirubin elevations; no further details provided).
Lee JL, Gooley T, Bensinger W, Schiffman K, McDonald GB. (1999). Veno-occlusive disease of the liver after busulfan, melphalan, and thiotepa conditioning therapy: incidence, risk factors, and outcome. Biol Blood Marrow Transplant. (Among 253 patients who received a regimen of busulfan, melphalan and thiotepa in preparation for HCT, 70 [28%] developed SOS, which was severe in 11 and fatal in 9 [4%]).
Alexander HR, Libutti SK, Bartlett DL, Puhlmann M, Fraker DL, Bachenheimer LC. (2000). A phase I-II study of isolated hepatic perfusion using melphalan with or without tumor necrosis factor for patients with ocular melanoma metastatic to liver. Clin Cancer Res. (Among 22 patients with melanoma metastatic to liver treated with isolated liver perfusion with hyperthermia, melphalan and tumor necrosis factor [TNF], 82% had ALT elevations [with or without TNF] and 68% had bilirubin elevations, 1 dying of multiorgan failure).
Christoforidis D, Martinet O, Lejeune FJ, Mosimann F. (2002). Isolated liver perfusion for non-resectable liver tumours: a review. Eur J Surg Oncol. (Review of isolated liver perfusion with melphalan [with or without tumor necrosis factor] as therapy of nonresectable liver tumors; liver failure and deaths have been reported due to SOS, coagulopathy, tumor replacement of the liver and hyperthermia-ischemia injury; elevations of ALT to 5-20 times ULN is common as is jaundice with bilirubin levels of 3 to 10 mg/dL).
Bouyn CI, Leclere J, Raimondo G, Le Pointe HD, Couanet D, Valteau-Couanet D, Hartmann O. (2003). Hepatic focal nodular hyperplasia in children previously treated for a solid tumor. Incidence, risk factors, and outcome. Cancer. (Retrospective analysis of 14 cases of focal nodular hyperplasia identified in children who had been treated for malignancy [neuroblastoma, sarcoma, germ cell tumors] with busulfan [n=9], melphalan [n=9], radiation [n=6] and bone marrow transplantation [n=1] in the distant past [4-21 years], usually found incidentally by ultrasound and not associated with symptoms or liver test abnormalities).
Kusumi E, Kami M, Kanda Y, Murashige N, Seki K, Fujiwara M, Koyama R, et al. (2006). Hepatic injury following reduced intensity unrelated cord blood transplantation for adult patients with hematological diseases. Biol Blood Marrow Transplant. (Among 85 patients undergoing allogenic cord blood transplantation after ablative therapy with melphalan or busulfan combined with fludarabine and total body irradiation; 87% developed hyperbilirubinemia and 19% had ALT elevations >5 times ULN, the usual causes being graft-vs-host disease and sepsis).
Zorzi D, Laurent A, Pawlik TM, Lauwers GY, Vauthey J-N, Abdalla EK. (2007). Chemotherapy-associated hepatotoxicity and surgery for colorectal liver metastases. Brit J Surg. (Systematic review of liver toxicity occurring after preoperative systemic chemotherapy for colorectal liver metastases, focuses upon steatosis caused by irinotecan and many other agents, SOS from oxiplatin and sclerosing cholangitis from fluoxuridine).
van Iersel LB, Verlaan MR, Vahrmeijer AL, van Persijn van Meerten EL, Tijl FG, Sparidans RW, Gelderblom H, et al. (2007). Hepatic artery infusion of high-dose melphalan at reduced flow during isolated hepatic perfusion for the treatment of colorectal metastases confined to the liver: a clinical and pharmacologic evaluation. Eur J Surg Oncol. (Among 30 patients with nonresectable liver metastases undergoing isolated hepatic perfusion with melphalan, most developed hepatic toxicity, 4 had sinusoidal obstruction syndrome, one died of liver failure and two developed portal hypertension).
Carreras E, Rosinol L, Terol MJ, Alegre A, de Arriba F, Garcia-Larana J, Bello JL, et al. (2007). Veno-occlusive disease of the liver after high-dose cytoreductive therapy with busulfan and melphalan for autologous blood stem cell transplantation in multiple myeloma patients. Biol Blood Marrow Transplant. (Among 734 patients undergoing autologous HCT for multiple myeloma, SOS occurred in 8% [19 of 240 with 2% mortality, median onset 29 days] receiving busulfan and melphalan, but in only 0.4% [2 of 494: 0.2% mortality, onset 9-13 days] receiving melphalan alone).
Mocellin S, Pilati P, Da Pian P, Forlin M, Corazzina S, Rossi CR, Innocente F, et al. (2007). Correlation between melphalan pharmacokinetics and hepatic toxicity following hyperthermic isolated liver perfusion for unresectable metastatic disease. Ann Surg Oncol. (Among 20 patients with nonresectable liver metastases undergoing isolated 60 minute hepatic perfusions with hyperthermia and melphalan, all patients developed hepatic injury, which was severe in 55% and fatal in 15%; degree of hepatotoxicity correlated with higher melphalan perfusate levels but not with tumor response, melphalan dose, body weight or other clinical features).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, antineoplastic agents were rarely implicated: 3 were considered due to mercaptopurine and 1 each due to bortezombin, cyclophosphamide, docetaxel, and temozolomide).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but few anticancer drugs were implicated [1 case each for melphalan and gemtuzumab]).
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of HCT, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents).
Yamamoto M, Zager JS. (2014). Isolated hepatic perfusion for metastatic melanoma. J Surg Oncol. (Review of the technique, efficacy and safety of isolated hepatic perfusion as therapy of metastatic melanoma, usually with melphalan with or without tumor necrosis factor as chemotherapy; no discussion of hepatotoxicity).
Voron T, Zinzindohoué F, Journois D, Hervé C, Ponzio O, Lucas N. (2013). Hyperthermic isolated liver perfusion with melphalan and bevacizumab. J Visc Surg. (Two patients with unresectable liver cancers underwent isolated 1-hr, hyperthermic liver perfusion with melphalan and bevacizumab without evidence of hepatic failure, SOS or residual portal hypertension).
Landau H, Hassoun H, Rosenzweig MA, Maurer M, Liu J, Flombaum C, Bello C, et al. (2013). Bortezomib and dexamethasone consolidation following risk-adapted melphalan and stem cell transplantation for patients with newly diagnosed light-chain amyloidosis. Leukemia. (Among 40 patients with amyloidosis who were treated with 3 doses of melphalan followed by HCT with or without consolidation with bortezomib and dexamethaxone, side effects were common, but no patient developed serious, clinically apparent hepatic toxicity).
Reddy SK, Kesmodel SB, Alexander HR. (2014). Isolated hepatic perfusion for patients with liver metastases. Ther Adv Med Oncol. (Review of isolated hepatic perfusion, including details of the procedure, clinical results and toxicity, mentions that the most common adverse event was ALT elevations [Grade III or above] occurring in 65% of patients).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 10 were attributed to antineoplastic agents, but none to melphalan).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. PMID: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, including 3 to alkylating agents, but none to melphalan).
Laemmle A, Hahn D, Hu L, Rüfenacht V, Gautschi M, Leibundgut K, Nuoffer JM, et al. (2015). Fatal hyperammonemia and carbamoyl phosphate synthetase 1 (CPS1) deficiency following high-dose chemotherapy and autologous hematopoietic stem cell transplantation. Mol Genet Metab. (A 2 year old with neuroblastoma developed severe hyperammonemia 7 days after completing myeloablation with carboplatin, etoposide and melphalan followed by HCT [NH3 475 umol/L, lactate 9.2 mmol/L] despite normal bilirubin and liver tests and a liver biopsy showing “no further signs of liver disease”, biochemical testing showing marked decreases in urea cycle enzyme activity and levels despite normal gene sequences and mRNA levels suggesting impaired mitochondrial function).
Moon WR, Moon DS, Kim J, Yoon YM, Choi BS, Chung CH, Park SG. (2015). Reactivation of hepatitis B (reverse seroconversion) after melphalan/dexamethasone therapy for primary amyloidosis: a case report. J Med Case Rep. (A 77 year old Korean man with primary amyloidosis developed reactivation of hepatitis B after 6 cycles of melphalan with dexamethasone [doses not given] despite being HBsAg negative and anti-HBs positive before therapy [bilirubin 1.3 mg/dL, ALT 496 U/L, HBsAg positive, HBeAg positive, HBV DNA ~ 67 million copies/mL], responding with clearance of HBsAg and normalization of ALT after entecavir therapy).
Hughes MS, Zager J, Faries M, Alexander HR, Royal RE, Wood B, Choi J, et al. (2016). Results of a randomized controlled multicenter phase III trial of percutaneous hepatic perfusion compared with best available care for patients with melanoma liver metastases. Ann Surg Oncol. (Among 93 patients with melanoma metastatic to the liver enrolled in a randomized controlled trial, overall survival was not different in those treated with percutaneous hepatic perfusion with melphalan vs standard therapy, although side effects were greater and 4 patients died of complications although none from liver injury which was scored as Grade III/IV in 14% of subjects).
Kirstein MM, Marquardt S, Jedicke N, Marhenke S, Koppert W, Manns MP, Wacker F, et al. (2017). Safety and efficacy of chemosaturation in patients with primary and secondary liver tumors. J Cancer Res Clin Oncol. (Among 29 patients treated with percutaneous hepatic perfusion with melphalan and hemofiltration of the hepatic venous outflow for various hepatic metastases or primary liver cancers, 19% had an objective response and major toxicities were largely hematologic and transient, ALT elevations rising above 5 times ULN in 17% generally in the week following the procedure and resolving in all).
Vogel A, Gupta S, Zeile M, von Haken R, Brüning R, Lotz G, Vahrmeijer A, et al. (2017). Chemosaturation percutaneous hepatic perfusion: a systematic review. Adv Ther. (Description of results using a commercial delivery system for percutaneous hepatic perfusion of melphalan for unresectable liver tumors or metastases which concluded that it had “favorable tumor response rates” and an “acceptable safety profile”).
Vogl TJ, Koch SA, Lotz G, Gebauer B, Willinek W, Engelke C, Brüning R, et al. (2017). Percutaneous isolated hepatic perfusion as a treatment for isolated hepatic metastases of uveal melanoma: patient outcome and safety in a multi-centre study. Cardiovasc Intervent Radiol. (Among 18 patients with ocular melanoma and liver metastases treated with percutaneous isolated hepatic perfusion with melphalan, adverse events were frequent, including leukopenia, thrombocytopenia, fever and edema; no mention of ALT elevations or hepatotoxicity).
Abate ME, Paioli A, Cammelli S, Cesari M, Longhi A, Palmerini E, Ferrari S, et al. (2018). Sinusoidal obstruction syndrome/veno-occlusive disease after high-dose intravenous busulfan/melphalan conditioning therapy in high-risk Ewing Sarcoma. Bone Marrow Transplant. (Among 75 patients with Ewing sarcoma treated with busulfan and melphalan followed by HCT, 5 developed moderate-to-severe SOS [7%], all arising in adults [5/43: 12%], mostly males [4/48: 8%] or with a history of radiation therapy [4/32: 13%]).
Artzner C, Mossakowski O, Hefferman G, Grosse U, Hoffmann R, Forschner A, Eigentler T, et al. (2019). Chemosaturation with percutaneous hepatic perfusion of melphalan for liver-dominant metastatic uveal melanoma: a single center experience. Cancer Imaging. (Among 16 patients with uveal melanoma and liver metastases treated with 28 courses of percutaneous hepatic perfusion, a partial response occurred in 9 [60%] but adverse events were common, including “liver toxicity” in 46% of courses, which was mild [Grade I] in all).
Meijer TS, Burgmans MC, Fiocco M, de Geus-Oei LF, Kapiteijn E, de Leede EM, Martini CH, et al. (2019). Safety of percutaneous hepatic perfusion with melphalan in patients with unresectable liver metastases from ocular melanoma using the Delcath Systems' second-generation hemofiltration system: a prospective non-randomized phase II trial. Cardiovasc Intervent Radiol. (Among 35 patients with ocular melanoma with liver metastases treated with 67 courses of percutaneous hepatic perfusion with melphalan using a new hemofiltration system, there were 14 serious mostly hematologic adverse events, none hepatic although aminotransferase elevations arose the majority of patients, all were mild and resolved within 16 days of the procedure).

## OTHER REFERENCE LINKS

1 Recent References on Melphalan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Melphalan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Melphalan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Melphalan)